# Adverse Drug Reaction Probability Scale (Naranjo) in Drug Induced Liver Injury

The Adverse Drug Reaction (ADR) Probability Scale was developed in 1991 by Naranjo and coworkers from the University of Toronto and is often referred to as the Naranjo Scale. This scale was developed to help standardize assessment of causality for all adverse drug reactions and was not designed specifically for drug induced liver injury. The scale was also designed for use in controlled trials and registration studies of new medications, rather than in routine clinical practice. Nevertheless, it is simple to apply and widely used. Many publications on drug induced liver injury mention results of applying the ADR Probability Scale.

The ADR Probability Scale consists of 10 questions that are answered as either Yes, No, or “Do not know”. Different point values (-1, 0, +1 or +2) are assigned to each answer. A simplified version of the 10 questions is provided below:

- Are there previous conclusive reports of this reaction?
- Did the adverse event appear after the drug was given?
- Did the adverse reaction improve when the drug was discontinued or a specific antagonist was given?
- Did the adverse reaction reappear upon readministering the drug?
- Were there other possible causes for the reaction?
- Did the adverse reaction reappear upon administration of placebo?
- Was the drug detected in the blood or other fluids in toxic concentrations?
- Was the reaction worsened upon increasing the dose? Or, was the reaction lessened upon decreasing the dose?
- Did the patient have a similar reaction to the drug or a related agent in the past?
- Was the adverse event confirmed by any other objective evidence?

The actual ADR Probability Scale form and instructions on how it is completed are provided below. Total scores range from -4 to +13; the reaction is considered definite if the score is 9 or higher, probable if 5 to 8, possible if 1 to 4, and doubtful if 0 or less.

While this scale includes all of the usual features that are important in assessing causality, the scale is not weighted for the most critical elements in judging the likelihood of drug induced liver injury, such as specific time to onset, criteria for time of recovery, and list of critical diagnoses to exclude, making the scale of limited use in assessing hepatotoxicity. The Naranjo scale also relies upon testing for drug levels, which is rarely helpful in idiosyncratic drug induced liver disease. Finally, the scale was designed for use in clinical trials, and points are subtracted if the reaction reappears with administration of placebo, which does not apply to the usual case of drug induced liver disease. Direct comparisons to the RUCAM system have shown that the ADR Probability Scale is easier to apply, but has less sensitivity and specificity in assigning causality to cases of drug induced liver injury.

## Naranjo Algorithm - ADR Probability Scale

Naranjo Adverse Drug Reaction Probability Scale Worksheet (PDF – 100 KB)

The Naranjo Algorithm, or Adverse Drug Reaction Probability Scale, is a method by which to assess whether there is a causal relationship between an identified untoward clinical event and a drug using a simple questionnaire to assign probability scores.

### Adverse Drug Reaction Probability Scale

Question | Yes | No | Do Not Know | Score
1 Are there previous conclusive reports on this reaction? | +1 | 0 | 0
2. Did the adverse event appear after the suspected drug was administered? | +2 | -1 | 0
3. Did the adverse event improve when the drug was discontinued or a specific antagonist was administered? | +1 | 0 | 0
4. Did the adverse event reappear when the drug was readministered? | +2 | -1 | 0
5. Are there alternative causes that could on their own have caused the reaction? | -1 | +2 | 0
6. Did the reaction reappear when a placebo was given? | -1 | +1 | 0
7. Was the drug detected in blood or other fluids in concentrations known to be toxic? | +1 | 0 | 0
8. Was the reaction more severe when the dose was increased or less severe when the dose was decreased? | +1 | 0 | 0
9. Did the patient have a similar reaction to the same or similar drugs in any previous exposure? | +1 | 0 | 0
10. Was the adverse event confirmed by any objective evidence? | +1 | 0 | 0
| Total Score:

## Naranjo Algorithm - ADR Probability Scale

Score | Interpretation of Scores
Total Score ≥9 | Definite. The reaction (1) followed a reasonable temporal sequence after a drug or in which a toxic drug level had been established in body fluids or tissues, (2) followed a recognized response to the suspected drug, and (3) was confirmed by improvement on withdrawing the drug and reappeared on reexposure.
Total Score 5 to 8 | Probable. The reaction (1) followed a reasonable temporal sequence after a drug, (2) followed a recognized response to the suspected drug, (3) was confirmed by withdrawal but not by exposure to the drug, and (4) could not be reasonably explained by the known characteristics of the patient’s clinical state.
Total Score 1 to 4 | Possible. The reaction (1) followed a temporal sequence after a drug, (2) possibly followed a recognized pattern to the suspected drug, and (3) could be explained by characteristics of the patient’s disease.
Total Score ≤0 | Doubtful. The reaction was likely related to factors other than a drug.

## Instructions for Using the ADR Probability Scale

The response “Do not know” should be used sparingly and only when the quality of the data does not permit a “Yes” or “No” answer. “Do not know” can be applicable if the information is not available and also if the question is inapplicable to the case. When more than one drug is involved or suspected, the ADR Probability Scale is usually applied separately to each of the possible etiologic agents, and the drug with the highest score should be considered the causative agent. In addition, the potential of interaction should be evaluated.

Question 1. Are there previous conclusive reports on this reaction? The answer “Yes” (+1) applies if there have been two or more published reports in which the adverse reaction has been described in detail or if the adverse reaction is listed in a reliable source, such as a medical textbook, review article on the medication or on adverse drug reactions, or the product package insert. The response “No” applies when the adverse event has not been described previously or if only one report has been published, or if published reports were considered inconclusive or unconvincing. The answer “Do not know” is applicable only when there is no information, because the agent has not been available for an adequate period of time or has not been previously evaluated for this adverse reaction. The scores given for “No” and “Do not know” are the same (0), so it is not critical to decide between these two answers.

Question 2. Did the adverse event appear after the suspected drug was administered? This question evaluates the temporal relationship between the reaction and administration of the medication. The answer “Yes” (+2) applies if there is definitive evidence that the adverse event occurred after the medication was started. “No” (-1) applies when the adverse event developed before the first dose of the drug. “Do not know” (0) applies if the information is not available or is unclear.

Question 3. Did the adverse event improve when the drug was discontinued or a specific antagonist was administered? This question evaluates the response to dechallenge or stopping the medication. The answer “Yes” (+1) applies if the adverse event diminishes or disappears at any time after stopping the medication, or if the reaction disappears upon administration of a specific pharmacologic antagonist (for example, an anticholinergic given for a cholinergic reaction to physostigmine). The answer “No” (0) applies if the adverse event does not improve or improves in response to a nonspecific therapy or an antidote to another medication or treatment of the underlying disease. The answer “Do not know” (0) applies if the medication was not stopped or the subsequent course was unknown, inconclusive or unclear.

Question 4. Did the adverse event reappear when the drug was readministered? This question evaluates the response to rechallenge or reexposure. An answer of “Yes” (+2) indicates that the medication was stopped, the adverse event resolved or improved, and there was an unequivocal reappearance or worsening of the reaction when the medicine was restarted in a similar dose and by the same route. The Naranjo scale also allows for a “Yes” if the causal association is well known and rechallenge cannot be done for clinical or ethical reasons. An answer of “No” (-1) only applies if rechallenge was done, but the adverse event did not reappear or worsen. The answer “Do not know” (0) applies if rechallenge was not done or information on rechallenge is not available or the reaction was ambiguous.

Question 5. Are there alternative causes that could on their own have caused the reaction? This question assesses alternative explanations for the adverse event. Because adverse events are often nonspecific and can be manifestations of the disease being treated or an unrelated, concurrent disease or condition, other diagnoses need to be considered and excluded. The answer “No” (+2) applies if alternative causes have been excluded, based upon a systematic and complete evaluation, thus implicating the drug more strongly. A risk or susceptibility factor is not an alternative cause. The answer “Yes” (-1) applies when there is an alternative cause or explanation. “Do not know” (0) applies if the investigation of other causes is incomplete, inconclusive or was not done.

Question 6. Did the reaction reappear when a placebo was given? This question applies to clinical research studies in which a placebo was administered. The answer “Yes” (-1) applies if the medication was stopped and the adverse reaction resolved or improved conclusively, and there was an unequivocal reappearance of the adverse event after administration of placebo (single or double blind). The answer “No” (+1) applies if the reaction did not reappear or worsen after administration of placebo. “Do not know” (0) applies if placebo challenge was not done or the results were inconclusive.

Question 7. Was the drug detected in blood or other fluids in concentrations known to be toxic? This question applies specifically to dose dependent adverse reactions when blood, urine, tissue or other specimen concentrations of the medicine are available. The answer “Yes” (+1) applies if the concentration is in the accepted toxic or supratherapeutic range. “No” (0) applies if the concentration is below the toxic range. The answer “Do not know” (0) applies if drug levels are not available or are inconclusive.

Question 8. Was the reaction more severe when the dose was increased or less severe when the dose was decreased? This question evaluates the dose response relationship of medication and the adverse reaction. “Yes” (+1) applies if the adverse event was more severe or worsened when the dose of the medication was increased, or was less severe and improved when the dose was decreased. “No” (0) applies if there was no appreciable change in the severity of the adverse event with dose modification. “Do not know” (0) applies if the dose or regimen was not altered or the information was not available or inconclusive.

Question 9. Did the patient have a similar reaction to the same or similar drugs in any previous exposure? This question is directed at past medical history of adverse reactions to the same or a structurally related drug. “Yes” (+1) applies when there is documentation of a previous similar reaction to the specific drug or a related medication. “No” (0) applies when the patient does not have a previous exposure to the same medicine or when the patient did not develop the adverse reaction in a previous exposure to the same or related drugs. “Do not know” (0) applies when there is no information on previous reactions or the information is inconclusive.

Question 10. Was the adverse event confirmed by any objective evidence? The final question assesses the quality of the data on which the adverse event is assessed. “Yes” (+1) indicates that there is laboratory test documentation of the adverse event or that the event was directly observed by a qualified person (for example, a skin rash described in nursing or physician notes). The answer “No” (0) applies when neither laboratory tests nor direct clinical documentation can verify the reaction. “Do not know” (0) applies if there is no specific information available (no laboratory testing and no clinical description) or the information is inconclusive. The scores given for “No” and “Do not know” are the same (0), so it is not critical to decide between these two answers.

## Selected References

Naranjo CA, Busto U, Sellers EM, Sandor P, Ruiz I, Roberts EA, Janecek E, et al. (1981). A method for estimating the probability of adverse drug reactions. Clin Pharacol Ther. (Initial description of Naranjo system for assessing adverse drug reactions, giving -1 to +2 points for 10 items: prevous conclusive reports, time of onset, improvement on stopping, reappearance with reexposure, alternative causes, reappearance with placebo, drug levels, dose response, previous exposure and history, and confirmation by objective evidence with total scores that range from -4 to +13; kappa=0.64 to 0.71 in assessing 63 cases by 3 authors).
Busto U, Naranjo CA, Sellers EM. (1982). Comparison of two recently published algorithms for assessing the probability of adverse drug reactions. Br J Clin Pharmacol. (Comparison of two scales for adverse drug reactions found both to have interreviewer reliability of >95%, but the Naranjo scale was easier and faster to fill out).
Naranjo CA, Busto U, Sellers EM. (1982). Difficulties in assessing adverse drug reactions in clinical trials. Prog Neuropsychopharmacol Biol Psychiatry. (Overview on the difficulties of assessing adverse drug reactions and assigning severity and causality scores).
Garcia-Cortes M, Lucena MI, Pachkoria K, Borraz Y, Hidalgo R, Andrade RJ, Spanish Group for the Study of Drug-Induced Liver Disease. (2008). Evaluation of Naranjo adverse drug reactions probability scale in causality assessment of drug-induced liver injury. Aliment Pharmacol Ther. (Two reviewers evaluated 225 cases of suspected hepatotoxicity from the Spanish database using two causality scales; there was interreviewer agreement in only 45%, and kappa=0.17 for Naranjo compared to 72% and kappa=0.71 for RUCAM; the Naranjo scale had a low sensitivity [54%] and poor negative predictive value [29%]).